# Foscarnet

## OVERVIEW

### Introduction

Foscarnet a simple pyrophosphate molecule which has antiviral activity against many viruses and is used intravenously in therapy of serious cytomegalovirus infections, largely in immunocompromised patients. Foscarnet has been associated with mild-to-moderate serum aminotransferase elevations during intravenous therapy, but not with episodes of clinically apparent liver injury.

### Background

Foscarnet (fos kar' net) is a pyrophosphate (phosphonoformate) that has antiviral activity against several DNA viruses, including cytomegalovirus (CMV) and hepatitis B virus. Foscarnet appears to act by inhibition of the pyrophosphate binding sites of viral DNA polymerases. Foscarnet is poorly absorbed orally and must be given intravenously. Foscarnet was approved for use in the United States in 1991, but has had limited use. Current indications include therapy of CMV retinitis and acyclovir-resistant herpes simplex infections in immunocompromised individuals. Foscarnet is available as an intravenous formulation of 24 mg/mL generically and previously under the brand name of Foscavir. The recommended dose in adults is 40 to 60 mg/kg intravenously every 8 to 12 hours for 2 to 4 weeks, which must be carefully monitored and dose adjusted for renal insufficiency. Side effects include headache, dizziness, confusion, fever, fatigue, abdominal pain, bone marrow suppression, renal dysfunction and rash. Uncommon but potentially severe adverse events include renal failure, seizures, hypersensitivity reactions, Stevens Johnson syndrome and rhabdomyolysis.

### Hepatotoxicity

Intravenous foscarnet therapy is associated with mild-to-moderate serum ALT elevations in a proportion of patients, but the drug is usually given to patients with multiorgan disease and conditions that may be associated with some degree of hepatic injury. The ALT elevations are usually asymptomatic and resolve even with continuation of foscarnet. Single case reports of clinically apparent liver injury that were possibly attributable to foscarnet have been reported. The pattern of injury was cholestatic arising within weeks of starting foscarnet but the clinical features of the liver injury have not been described in any detail.

Likelihood score: D (possible cause of clinically apparent liver injjry).

### Mechanism of Injury

Foscarnet is rapidly excreted in the urine and has little hepatic metabolism, which may account for its relative lack of hepatotoxicity. Acute liver injury during foscarnet therapy might be a result of a hypersensitivity reaction to the drug or of a complication of the condition for which foscarnet was used.

### Outcome and Management

The serum aminotransferase elevations during foscarnet therapy are usually self-limited and do not require dose adjustment. Foscarnet is usually given to severely immunocompromised patients who are frequently on multiple other medications, many of which may be hepatotoxic and attribution of hepatic injury in such individuals can be difficult.

Drug Class: Antiviral Agents

Other Antiviral Agents for Herpes Virus Infections: Acyclovir, Cidofovir, Famciclovir, Ganciclovir, Letermovir, Valacyclovir, Valganciclovir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Foscarnet – Generic, Foscavir®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Foscarnet)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Foscarnet | 4428-95-9 | C-H3-O5-P | Foscarnet Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 06 February 2018

Zimmerman HJ. Antiviral agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 621-3. (Expert review of antiviral agents and liver injury published in 1999; mentions that foscarnet "...has not been reported to lead to hepatic injury").
Núñez M. Hepatotoxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 513. (Review of hepatotoxicity of antiviral agents states that ALT and AST elevations occurred in 1-5% of patients treated with foscarnet in clinical trials).
Acosta EP, Flexner C. Antiviral agents (nonretroviral). In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1602-3. (Textbook of pharmacology and therapeutics; foscarnet must be given parenterally to achieve adequate drug levels for its antiviral action; dose limiting side effects are nephrotoxicity and hypocalcemia).
Ringdén O, Lönnqvist B, Paulin T, Ahlmén J, Klintmalm G, Wahren B, Lernestedt JO. Pharmacokinetics, safety and preliminary clinical experiences using foscarnet in the treatment of cytomegalovirus infections in bone marrow and renal transplant recipients. J Antimicrob Chemother 1986; 17: 373-87. (Experience in 57 episodes of severe CMV infection in 46 patients given intravenous foscarnet for 2 to 46 days; elevations in serum enzymes were frequen, but usually attributed to underlying conditions; one patient developed jaundice [bilirubin 0.7 rising to 7.1 mg/dL] with mild rise in Alk P; another had tremor, hallucinations and ALT elevations with high levels of foscarnet and renal failure). 3009383
Cacoub P, Deray G, Baumelou A, Le Hoang P, Rozenbaum W, Gentilini M, Soubrie C, et al. Acute renal failure induced by foscarnet: 4 cases. Clin Nephrol 1988; 29: 315-8. (Four case reports of acute renal failure in patients after 5-15 days of high dose foscarnet [5-12 g/day] for CMV retinitis, improving with stopping; liver tests were either normal or not mentioned). 2840226
Palestine AG, Polis MA, De Smet MD, Baird BF, Falloon J, Kovacs JA, Davey RT, et al. A randomized, controlled trial of foscarnet in the treatment of cytomegalovirus retinitis in patients with AIDS. Ann Intern Med 1991; 115: 665-73. (Controlled trial of foscarnet vs delayed therapy in 24 patients with CMV retinitis and HIV infection; one patient on foscarnet and zidovudine "developed cholestatic jaundice that resolved after both drugs were withdrawn"). 1656826
Chrisp P, Clissold SP. Foscarnet: a review of its antiviral activity, pharmacokinetic properties and therapeutic use in immunocompromised patients with cytomegalovirus retinitis. Drugs 1991; 41: 104-29. (Thorough review of antiviral activity, pharmacokinetics, efficacy and safety of foscarnet; "Foscarnet has negligible effects on hepatic function, only occasionally causing slight elevations in serum transaminase levels"). 1706982
Styrt B, Freiman JP. Hepatotoxicity of antiviral agents. Gastroenterol Clin North Am 1995; 24: 839-52. (Review of liver toxicity of antiviral agents; mentions that foscarnet has caused alterations in liver tests uncommonly [<1%]). 8749901
Drugs for non-HIV viral infections. Treat Guidel Med Lett 2007; 5: 59-70. (Review of status of non-antiretroviral antiviral agents for prevention and treatment of herpes, varicella-zoster, cytomegalovirus, influenza A and B, and hepatitis B and C; no mention of liver related side effects for foscarnet). 17565338
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 8 were attributed to antiviral agents including one due to valacyclovir, but none to foscarnet). 18955056
Ishiyama K, Katagiri T, Hoshino T, Yoshida T, Yamaguchi M, Nakao S. Preemptive therapy of human herpesvirus-6 encephalitis with foscarnet sodium for high-risk patients after hematopoietic SCT. Bone Marrow Transplant 2011; 46: 863-9. (Among 15 patients receiving hematopoietic cell transplantation, 8 received preemptive therapy with foscarnet for human herpesvirus-6 infection, among whom only 1 had liver enzyme elevations compared to 3 of 7 who did not receive foscarnet and none developed clinically apparent liver injury). 20838386
Antiviral drugs. Treat Guidel Med Lett 2013; 11 (127): 19-30. (Review of status of non-antiretroviral antiviral agents; foscarnet is used for acyclovir resistant varicella-zoster and herpes virus infections and for CMV retinitis in patients with AIDs; adverse effects include renal dysfunction, gastointestinal upset, CNS disturbances hypocalcemia and seizures; no mention of liver toxicity or ALT elevations). 23459414
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 [1.3%] were attributed to antiviral agents, but none to foscarnet). 25754159
Pierce B, Richardson CL, Lacloche L, Allen A, Ison MG. Safety and efficacy of foscarnet for the management of ganciclovir-resistant or refractory cytomegalovirus infections: a single center study. Transpl Infect Dis 2018 Jan 30. [Epub ahead of print] (Among 31 post-solid organ transplant patients who received foscarnet, side effects were common but related mostly to renal dysfunction; no mention of ALT elevations or hepatotoxicity and none of 10 deaths were due to liver failure). 29380479

## OTHER REFERENCE LINKS

1. Recent References on Foscarnet: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Foscarnet/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Foscarnet: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Foscarnet)